# Cenobamate

## OVERVIEW

### Introduction

Cenobamate is a tetrazole carbamate anticonvulsant used as therapy of partial onset seizures in adults. Cenobamate is associated with a low-to-moderate rate of serum aminotransferase elevations during therapy and has been linked to cases of clinically apparent liver injury usually in the context of a multiorgan hypersensitivity syndrome such as drug reaction with eosinophilia and systemic symptoms (DRESS).

### Background

Cenobamate (sen” oh bam’ ate) is a novel tetrazole alkyl carbamate anticonvulsant that reduces repetitive neuronal firing by inhibiting voltage-gated sodium channels. It also is a positive allosteric modulator of GABA_A_ ion channels. In several controlled trials, cenobamate was shown to be effective in reducing focal-onset seizures in patients refractory to conventional therapy. Cenobamate was approved for use in the United States in 2020. Current indications include therapy of partial-onset seizures in adults. Cenobamate is available in tablets of 12.5, 25, 50, 100, 150 and 200 mg under the brand name Xcopri. The recommended initial dose is 12.5 mg once daily with subsequent increases to 25, 50, 100, 150 and 200 mg daily every two weeks (12 week initial titration period). The recommended maintenance dose is 200 mg daily in adults, and maximum daily dose is 400 mg. Side effects include fatigue, somnolence, dizziness, diplopia and headaches. Rare, but potentially severe adverse events include severe nausea and vomiting, prolongation of the QT interval, suicidal ideation and behaviors, cognitive dysfunction, rash, and multiorgan hypersensitivity reactions including drug reaction with eosinophilia and systemic symptoms (DRESS syndrome). The prolonged, slow titration period is believed to help prevent the more severe side effects.

### Hepatotoxicity

In controlled clinical trials, addition of cenobamate to standard anticonvulsant therapy was associated with transient, mild-to-moderate serum aminotransferase elevations in 1% to 4% of patients. In the preregistration trials of cenobamate, there were no cases of clinically apparent liver injury with jaundice. However, among 953 patients with exposure to cenobamate in these trials, there were three cases of DRESS syndrome accompanied by serum aminotransferase elevations, which arose during the first 3 to 6 weeks of treatment in subjects who had a relative rapid initial titration (4 to 6 weeks). In large open label studies using a more prolonged titration period (12 weeks), no instances of DRESS syndrome were reported among more than 1000 participants. Felbamate, a structurally related carbamate anticonvulsant, is a well-known cause of drug induced liver injury and has a boxed warning and restricted availability because of severe hypersensitivity reactions including acute liver failure and aplastic anemia. Thus, clinically significant liver injury from cenobamate may occur and can be severe, but is rare.

Likelihood score: D (possible rare cause of clinically apparent liver injury in the context of generalized hypersensitivity syndrome).

### Mechanism of Injury

Cenobamate is a carbamate anticonvulsant and is metabolized extensively in the liver via several of the cytochrome P450 enzymes. Cenobamate is a weak inhibitor of CYP 2C19 and an inducer of CYP 2B6, 2C8 and 3A4 and thus capable of causing drug-drug interactions. In higher doses it can cause euphoria and it is classified as a Schedule V drug with potential for dependency and abuse.

### Outcome and Management

Patients who have developed serious hypersensitivity reactions to cenobamate should discontinue therapy promptly and avoid reexposure. The potential cross reactivity of hypersensitivity reactions to cenobamate with the aromatic anticonvulsants, such as phenytoin, carbamazepine and lamotrigine, is unknown. The structure of cenobamate would suggest that it may share sensitivity to other anticonvulsant agents.

Drug Class: Anticonvulsants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cenobamate – Xcopri®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cenobamate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Cenobamate | 913088-80-9 | C10-H10-Cl-N5-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 18 August 2021

Abbreviation used: DRESS, drug reaction with eosinophilia and systemic symptoms.

Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999 before the availability of cenobamate).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-42. (Review of anticonvulsant induced liver injury; cenobamate is not discussed).
Smith MD, Metcalf CS, Wilcox KS. Pharmacology of the epilepsies. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 303-26. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/212839Orig1s000MedR.pdf (FDA review of efficacy and safety of cenobamate, in support of its approval in the US, mentions that higher doses of cenobamate were associated with small increases in ALT levels but only 5 treated subjects [and no placebo recipients] developed transient ALT levels more than twice ULN, but more strikingly 3 patients developed DRESS syndrome [after 24-32 days] with fever, rash, facial swelling and other organ involvement including serum ALT elevations [peak values 1327, 568 and 158 U/L]; one patient dying due to eosinophilic myocarditis; all three subjects had a rapid [weekly] titration of dose).
Vidaurre J, Gedela S, Yarosz S. (2017). Antiepileptic drugs and liver disease. Pediatr Neurol. (Review of the use of anticonvulsants in patients with liver disease recommends use of agents that have little hepatic metabolism such as levetiracetam, lacosamide, topiramate, gabapentin and pregabalin, levetiracetam being an "ideal" first line therapy for patients with liver disease because of its safety and lack of pharmacokinetic interactions).
(2017). Drugs for epilepsy. Med Lett Drugs Ther. (Concise review of the drugs available for therapy of epilepsy; does not discuss cenobamate).
Borrelli EP, Lee EY, Descoteaux AM, Kogut SJ, Caffrey AR. (2018). Stevens-Johnson syndrome and toxic epidermal necrolysis with antiepileptic drugs: An analysis of the US Food and Drug Administration Adverse Event Reporting System. Epilepsia. (Review of adverse event reports to the FDA between 2014 and 2018 identified ~2.9 million reports, 1034 for SJS/TEN, the most common class of drugs being anticonvulsants with 17 of 34 having at least one report, those most frequently linked being lamotrigine [n=106], carbamazepine [22], levetiracetam [14], phenytoin [14], valproate [9], clonazepam [8] and zonisamide [7]; cenobamate is not discussed).
Krauss GL, Klein P, Brandt C, Lee SK, Milanov I, Milovanovic M, Steinhoff BJ, et al. (2020). Safety and efficacy of adjunctive cenobamate (YKP3089) in patients with uncontrolled focal seizures: a multicentre, double-blind, randomised, placebo-controlled, dose-response trial. Lancet Neurol. (Among 434 adults with uncontrolled focal-onset epilepsy treated with cenobamate [100, 200 or 400 mg] or placebo once daily for 6 weeks of titration and 12 weeks of maintenance, changes in seizure frequency were -35.5%, -55% and -55% with cenobamate vs -24% for placebo, and common adverse events were somnolence, dizziness, headache, fatigue and ataxia while 3 patients had hypersensitivity reactions including one with DRESS arising at day 24, resolving with discontinuation and corticosteroid therapy).
Keam SJ. (2020). Cenobamate: first approval. Drugs. (Review of the structure, mechanism of action, history of development, pharmacology, clinical efficacy and safety of cenobamate mentions common [>10%] side effects of somnolence, dizziness, fatigue, diplopia, and headache and rare serious adverse events of DRESS syndrome, which occurred in 3 of the first 953 patients exposed; no drug related fatalities).
Vossler DG. (2020). Remarkably high efficacy of cenobamate in adults with focal-onset seizures: a double-blind, randomized, placebo-controlled trial. Epilepsy Curr. (Commentary on the placebo controlled study of cenobamate [Krauss 2020] mentions that the seizure-free rate in these refractory patients was 21% for cenobamate [400 mg] vs 1% for placebo, which is much higher than other anticonvulsants [0% to 6.5%] and that cases of DRESS syndrome were seen only with relatively rapid initial titration periods).
Sperling MR, Klein P, Aboumatar S, Gelfand M, Halford JJ, Krauss GL, Rosenfeld WE, et al. (2020). Cenobamate (YKP3089) as adjunctive treatment for uncontrolled focal seizures in a large, phase 3, multicenter, open-label safety study. Epilepsia. (Among 1347 patients enrolled in an open label study of cenobamate for uncontrolled focal seizures with an initial 12-week titration phase with a median duration of therapy of 9 months, 20% of patients discontinued treatment, 10% because of adverse events, but there were no instances of DRESS syndrome or serious hepatic adverse events).
Chung SS, French JA, Kowalski J, Krauss GL, Lee SK, Maciejowski M, Rosenfeld WE, et al. (2020). Randomized phase 2 study of adjunctive cenobamate in patients with uncontrolled focal seizures. Neurology. (Among 222 patients with refractory focal seizures treated with cenobamate [200 mg] or placebo once daily for 12 weeks [6 week titration and 6 week maintenance], seizure frequency decreased by 56% on cenobamate vs 22% on placebo and adverse events were mostly mild-to-moderate, one patient developing a hypersensitivity reaction with the first dose [rash, itching responding to antihistamines], and there were “no clinically meaningful trends in changes from baseline in mean laboratory values”).
(2020). Cenobamate (Xcopri) for focal seizures. Med Lett Drugs Ther. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of cenobamate shortly after its approval in the US mentions that adverse events are largely dose related and can include shortening of the QT interval, drug-drug interactions, physical dependence, and DRESS syndrome).
Elizebath R, Zhang E, Coe P, Gutierrez EG, Yang J, Krauss GL. (2021). Cenobamate treatment of focal-onset seizures: Quality of life and outcome during up to eight years of treatment. Epilepsy Behav. (Among 49 patients with refractory focal-onset seizures enrolled from a single medical center into controlled trials of cenobamate, 37 of whom continued on open label therapy for 3-8 years, 45% achieved a 75% reduction in seizure frequency, and adverse events included one case of DRESS syndrome with liver enzyme elevations occurring during the first few months of therapy and while seizure-free, the syndrome resolving on stopping therapy but seizure activity then resumed).
Roberti R, De Caro C, Iannone LF, Zaccara G, Lattanzi S, Russo E. (2021). Pharmacology of cenobamate: mechanism of action, pharmacokinetics, drug-drug interactions and tolerability. CNS Drugs. (Review of the pharmacokinetics, mechanisms of action, drug-drug interactions and safety of cenobamate mentions that its pharmacokinetics are not linear and it has many drug-drug interactions and important side effects including hypersensitivity reactions and shortening of the QT interval).
Latimer DR, Edinoff AN, Ruff RD, Rooney KC, Penny KM, Patel SB, Sabbenahalli S, et al. (2021). Cenobamate, a sodium channel inhibitor and positive allosteric modulator of GABA_A_ ion channels, for partial onset seizures in adults: a comprehensive review and clinical implications. Neurol Int. (Review of the mechanism of action, clinical efficacy and safety of cenobamate discusses its activity as a positive allosteric modulator of GABA_A_ ion channels and inhibition of voltage-gated sodium channels).
French JA, Chung SS, Krauss GL, Lee SK, Maciejowski M, Rosenfeld WE, Sperling MR, et al. (2021). Long-term safety of adjunctive cenobamate in patients with uncontrolled focal seizures: open-label extension of a randomized clinical study. Epilepsia. (Among 149 patients enrolled in an open-label extension study after participating in controlled trials of cenobamate, adverse events arose in 89%, resulted in discontinuation in 10%, were serious in 26% [including seizures, vomiting, pneumonia, sepsis and osteoarthritis], and resulted in death in 3 patients, one from suicide; no mention of DRESS, ALT elevations, hepatotoxicity or serious hepatic adverse events).

## OTHER REFERENCE LINKS

1 Recent References on Cenobamate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Cenobamate+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Cenobamate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cenobamate)